# Sebelipase alfa

## OVERVIEW

### Introduction

Lysosomal acid lipase deficiency is an inherited condition which underlies Wolman disease and cholesteryl ester storage disease. The current standard treatment for these two conditions is enzyme replacement therapy using infusions of recombinant forms of lysosomal acid lipase. Enzyme replacement therapy is generally well tolerated and has not been linked to serum enzyme elevations or to instances of clinically apparent acute liver injury.

### Background

Sebelipase (se" be lye' pase) alfa is a recombinant form of the lysosomal enzyme that is absent or deficient in inherited conditions that are marked by dyslipidemia, early onset of atherosclerosis and fatty liver disease that can progress to cirrhosis. The severe form of lysosomal acid lipase deficiency is known as Wolman disease in which the enzyme is entirely absent. Wolman disease is a severe, progressive disease of infancy marked by severe diarrhea, failure to thrive and progressive hepatic fibrosis and cirrhosis, usually leading to death within the first year of life. The same enzyme defect also appears to be responsible for the milder form of dyslipidemia and liver disease known as cholesterol ester storage disease in which the enzyme is deficient, but not totally absent. Cholesterol ester storage disease typically presents in adolescence or young adulthood, but may go undetected and present with middle age with wide spread complications of atherosclerosis or cirrhosis of unknown cause. The enzyme acts in lysosomes upon cholesterol esters and its deficiency results in accumulation of the cholesterol esters and triglycerides in hepatocytes and diffusely in macrophages in the liver, spleen, adrenals, bone marrow, lymph nodes and intestinal villi. Liver histology demonstrates microvesicular steatosis, foamy macrophages and progressive fibrosis. Serum aminotransferase levels are typically mildly or moderately elevated. Cholesterol lowering agents have been used in an attempt to treat these conditions, but have little effect. Cirrhosis and end stage liver disease can be managed successfully with liver transplantation, and hematopoietic cell transplantation has been reported to reverse some of the manifestations. Recently, infusions of recombinant lysosomal acid lipase have been found to decrease serum enzyme elevations and result in resolution of hepatomegaly in patients with cholesterol ester storage disease. In some cases, the beneficial effects were dramatic with evidence of disease regression. Pilot studies in children with Wolman disease have also had promising results with enzyme replacement. Sebelipase alfa, a recombinant lysosomal acid lipase product extracted from the egg whites laid by transgenic hens, was approved for use in lysosomal acid lipase deficiency in 2015. The recombinant protein is available in solution in single use vials of 2 mg/mL under the brand name Kanuma. The recommended regimen of therapy varies by indication, but is in the range of 1 to 3 mg/kg infused intravenously every 1 to 2 weeks. Side effects are few but can include infusion reactions and hypersensitivity.

### Hepatotoxicity

In preregistration controlled trials, lysosomal acid lipase enzyme replacement therapy usually resulted in a rapid improvement in serum enzyme elevations, which was used as a surrogate marker for efficacy in ameliorating the liver disease caused by the lysosomal acid lipase deficiency. No reports of de novo serum aminotransferase elevations or clinically apparent liver injury were reported in trials of sebelipase alfa infusion therapy. Anti-drug reactive antibodies develop in a proportion of patients (particularly those with Wolman disease) and can be associated with hypersensitivity reactions, but these have not been linked to episodes of liver injury and can usually be managed with antihistamines and do not necessitate permanent discontinuation of treatment.

Likelihood score: E (unlikely cause of clinically apparent acute liver injury).

### Mechanism of Injury

Sebelipase alfa is a recombinant protein that shares 99% homology with the human enzyme. Proteins are metabolized in multiple organs and tissues into polypeptides and amino acids. There is no reason for these proteins to cause liver disease other than by a hypersensitivity reaction or by their direct enzymatic reactivity.

### Outcome and Management

Serum enzyme elevations that occur on enzyme replacement therapies are usually self-limited and mild and generally do not require dose modification or discontinuation of therapy. Persistent or prominent elevations should lead to evaluation for other forms of liver disease. No instances of acute liver failure, chronic hepatitis or vanishing bile duct syndrome due to sebelipase have been reported.

Drug Class: Lysosomal Acid Lipase Deficiency Agents; Enzyme Replacement Therapy

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Sebelipase alfa – Kanuma®

DRUG CLASS

Lysosomal Acid Lipase Deficiency Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Sebelipase)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Sebelipase alfa | 1276027-63-4 | Protein | Not Available

## ANNOTATED BIBLIOGRAPHY

References updated: 10 March 2016

Hoeg JM, Demosky SJ Jr, Pescovitz OH, Brewer HB Jr. Cholesteryl ester storage disease and Wolman disease: phenotypic variants of lysosomal acid cholesteryl ester hydrolase deficiency. Am J Hum Genet 1984; 36: 1190-203. (Early description of the similarities and differences between Wolman disease and cholesterol ester storage disease points out the near absence of the lysosomal acid lipase in Wolman disease [<4%] and its marked deficiency in cholesterol ester storage disease [23%]). 6097111
Pagani F, Pariyarath R, Garcia R, Stuani C, Burlina AB, Ruotolo G, Rabusin M, et al. New lysosomal acid lipase gene mutants explain the phenotype of Wolman disease and cholesteryl ester storage disease. J Lipid Res 1998; 39: 1382-8. (Analysis of the variants in the gene of lysosomal acid lipase found mutations that distinguish Wolman disease [missense substitutions] and cholesterol ester storage disease [splicing errors]). 9684740
Anderson RA, Bryson GM, Parks JS. Lysosomal acid lipase mutations that determine phenotype in Wolman and cholesterol ester storage disease. Mol Genet Metab 1999; 68: 333-45. (Four of 5 patients with cholesterol ester storage disease had a splice junction mutation in at least one allele of the lysosomal acid lipase gene which encoded a shortened form of the enzyme, whereas all 3 with Wolman disease had missense mutations in both alleles accounting for the virtual absence of enzymatic activity). 10562460
Krivit W, Peters C, Dusenbery K, Ben-Yoseph Y, Ramsay NK, Wagner JE, Anderson R. Wolman disease successfully treated by bone marrow transplantation. Bone Marrow Transplant 2000; 26: 567-70. (6 month old girl with Wolman disease, whose brother had died at age 3 months, underwent bone marrow transplantation with subsequent partial resolution of symptoms and signs, and improved physical and mental development). 11019848
Elleder M, Chlumská A, Hyánek J, Poupĕtová H, Ledvinová J, Maas S, Lohse P. Subclinical course of cholesteryl ester storage disease in an adult with hypercholesterolemia, accelerated atherosclerosis, and liver cancer. J Hepatol 2000; 32: 528-34. (51 year old man was found to have advanced artherosclerotic peripheral artery disease, dyslipidemia and micronodular cirrhosis with cholangiocarcinoma, and genetic analysis showed evidence of lysosomal acid lipase deficiency characteristic of cholesterol ester storage disease). 10735626
Du H, Schiavi S, Levine M, Mishra J, Heur M, Grabowski GA. Enzyme therapy for lysosomal acid lipase deficiency in the mouse. Hum Mol Genet 2001; 10: 1639-48. (In a mouse model of Wolman disease, infusion of mannose terminated human lysosomal acid lipase resulted in uptake of the enzyme in macrophages and decrease in the excessive triglyceride and cholesterol content of the liver, spleen and small intestine). 11487567
Fasano T, Pisciotta L, Bocchi L, Guardamagna O, Assandro P, Rabacchi C, Zanoni P, et al. Lysosomal lipase deficiency: molecular characterization of eleven patients with Wolman or cholesteryl ester storage disease. Mol Genet Metab 2012; 105: 450-6. (All 8 patients with cholesterol ester storage disease, but none of 3 with Wolman disease, had a splice junction mutation in the lysosomal acid lipase gene, this mutation occurring within a common haplotype suggesting a common “founder” ancestor). 22227072
Bernstein DL, Hülkova H, Bialer MG, Desnick RJ. Cholesteryl ester storage disease: review of the findings in 135 reported patients with an underdiagnosed disease. J Hepatol 2013; 58: 1230-43. (Review of the clinical features of cholesterol ester storage disease based upon 135 patients reported in the literature, found in all races, both sexes with onset ranging from 1 to 68 years; 99% had hepatomegaly and 74% splenomegaly; all had elevations in ALT or AST, mean levels 54 and 52 U/L; cholesterol elevations in all, even with statin use; among 11 deaths, 73% were due to liver failure; liver biopsy findings were diagnostic; genetic analyses show at least 31 distinct mutations accounting for variation in residual enzyme activity and disease presentation: Wolman disease or cholesterol ester storage disease). 23485521
Balwani M, Breen C, Enns GM, Deegan PB, Honzík T, Jones S, Kane JP, et al. Clinical effect and safety profile of recombinant human lysosomal acid lipase in patients with cholesteryl ester storage disease. Hepatology 2013; 58: 950-7. (Phase 1 and 2 studies of recombinant lysosomal acid lipase [sebelipase alfa] in 9 adults with cholesterol ester storage disease found the infusions to be well tolerated and to result in decreases in serum cholesterol, ALT and AST levels with relapse upon stopping, and sustained improvements with extended therapy). 23348766
Grabowski G. Therapy for lysosomal acid lipase deficiency: replacing a missing link. Hepatology 2013; 58: 850-2. (Review of the role of lysosomal acid lipase in cholesterol metabolism, the consequences of its deficiency and the possible role of recombinant enzyme replacement therapy). 23471861
Valayannopoulos V, Malinova V, Honzík T, Balwani M, Breen C, Deegan PB, Enns GM, et al. Sebelipase alfa over 52 weeks reduces serum transaminases, liver volume and improves serum lipids in patients with lysosomal acid lipase deficiency. J Hepatol 2014; 61: 1135-42. (Among 8 adults with cholesterol ester storage disease treated in an open label extension study with infusions of sebelipase every other week for at least one year, serum ALT and AST levels became and remained normal and liver volume and fat content decreased; side effects included 2 hypersensitivity reactions in patients who later tolerated restarting treatment; no mention of liver injury or serum enzyme elevations). 24993530
Chuang JC, Lopez AM, Posey KS, Turley SD. Ezetimibe markedly attenuates hepatic cholesterol accumulation and improves liver function in the lysosomal acid lipase-deficient mouse, a model for cholesteryl ester storage disease. Biochem Biophys Res Commun 2014; 443: 1073-7. (In a mouse model of cholesterol ester storage disease, ezetimibe led to a decrease in hepatic cholesterol concentrations and improvements in serum ALT levels). 24370824
Reiner Ž, Guardamagna O, Nair D, Soran H, Hovingh K, Bertolini S, Jones S, et al. Lysosomal acid lipase deficiency--an under-recognized cause of dyslipidaemia and liver dysfunction. Atherosclerosis 2014; 235: 21-30. (Summary of the pathogenesis, genetic basis, clinical features and diagnosis of lysosomal acid lipase deficiency focuses upon need for screening and the frequency with which it is underdiagnosed). 24792990
Sun Y, Xu YH, Du H, Quinn B, Liou B, Stanton L, Inskeep V, et al. Reversal of advanced disease in lysosomal acid lipase deficient mice: a model for lysosomal acid lipase deficiency disease. Mol Genet Metab 2014; 112: 229-41. (In a mouse model of lysosomal acid lipase deficiency [lal-/-], infusions of recombinant human lysosomal acid lipase resulted in decreases in cholesterol levels in liver and spleen towards normal, less fibrosis accumulation in liver and prolongation of life in comparison to saline infusions). 24837159
Shirley M. Sebelipase Alfa: First Global Approval. Drugs 2015; 75: 1935-40. (Summary of history of development and approval of sebelipase alfa for therapy of lysosomal acid lipase deficiency mentions that the intravenous infusions result in prompt improvements in serum ALT levels and lessening of hepatomegaly). 26452566
Burton BK, Deegan PB, Enns GM, Guardamagna O, Horslen S, Hovingh GK, Lobritto SJ, et al. Clinical features of lysosomal acid lipase deficiency. J Pediatr Gastroenterol Nutr 2015; 61: 619-25. (Among 49 patients with lysosomal acid lipase deficiency enrolled in a prospective study, mean age of onset was 9 years; imaging showed hepatomegaly in 77%, splenomegaly 64% and steatosis 51%; ALT elevated in 92%, cholesterol in 63%, triglycerides in 27%). 26252914
Burton BK, Balwani M, Feillet F, Barić I, Burrow TA, Camarena Grande C, Coker M, et al. A phase 3 trial of sebelipase alfa in lysosomal acid lipase deficiency. N Engl J Med 2015; 373: 1010-20. (Among 66 patients [ages 4 to 54 years] with lysosomal acid lipase deficiency [38 with cirrhosis] treated with infusions of sebelipase or placebo every 2 weeks for 20 weeks, serum ALT, AST and cholesterol levels and hepatic volume and fat content improved more with active enzyme therapy than placebo; one patient had a mild hypersensitivity reaction but was able to continue therapy, and there were no hepatic adverse effects mentioned). 26352813
Rader DJ. Lysosomal acid lipase deficiency--a new therapy for a genetic lipid disease. N Engl J Med 2015; 373: 1071-3. (Editorial in response to Burton [2015] discusses the etiology, pathogenesis and long term consequences of lysosomal acid lipase deficiency and the rationale for a glycosylated, mannose-terminated recombinant enzyme that targets hepatocytes via the mannose-6-phosphate receptor). 26352819

## OTHER REFERENCE LINKS

1. Recent References on Sebelipase alfa: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Sebelipase+alfa/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Sebelipase alfa: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Sebelipase+alfa)